# Khat

## OVERVIEW

### Introduction

Khat is a stimulant derived from the fresh leaves of the evergreen shrub Catha edulis, which is native to parts of East Africa and the Arabian Peninsula. Chewing khat leaves is a well established social habit in areas where the shrub is endemic and causes a mild euphoria. Khat chewing has been implicated in causing rare but serious, clinically apparent acute and chronic liver injury.

### Background

Khat (pronounced "kaat") is a product of the leaves of the evergreen shrub Catha edulis that is native to Ethiopia, Kenya, North Yemen and Madagascar. Chewing the leaves releases a stimulant that is absorbed through the oral mucosa and results in mild stimulation, heightened sense of awareness and euphoria. Khat chewing is a common practice and social habit, particularly among men in areas of East Africa and the Arabian Peninsula where the shrub is endemic. Recently, immigrants from those countries have introduced the practice to other areas of the world, including North America, Europe, and Australia. The active ingredient of khat is believed to be phenylalkylamine alkaloids (cathinone, cathine and nor pseudoephedrine), which have sympathomimetic effects that resemble those of the amphetamines. Khat has no current medicinal use and is considered a drug of abuse with potentially serious psychological and neurological adverse effects. Khat is banned in the United States, but is legal and available in Africa, the Middle East, and some countries in Europe including the UK. Common side effects of chewing khat include excitation, confusion, decreased appetite, hyperactivity, hypertonia and hyperthermia. Chronic use has been linked to disruption of personal and family relations, depression, psychiatric problems, hypertension, myocardial infarction and stroke.

### Hepatotoxicity

There is little information of whether acute or chronic khat use is associated with serum enzyme elevations or alterations in liver function. However, in recent years several individual case reports and small case series of serious acute and chronic liver injury attributed to khat have been published, largely from the UK and Europe and in immigrants from areas of the world where khat use is frequent. The onset of injury usually occurs after years of khat use and can present acutely with nausea, fatigue, pruritus and jaundice or chronically, with signs and complications of portal hypertension. The pattern of liver enzyme elevations is typically hepatocellular and, in acute cases, the aminotransferase levels can be markedly elevated. Autoantibodies occur in a proportion of cases and the disease often resembles autoimmune hepatitis with chronic inflammation and fibrosis. However, responses to corticosteroid therapy are usually only partial, at least if khat use continued. Immunoallergic features (rash, fever, eosinophilia) are not common. Some patients suffer from multiple bouts of acute injury which leads to fibrosis and cirrhosis, portal hypertension and hepatic failure. Resolution occurs if khat chewing is stopped, but relapses are common, even in some patients who deny relapse in khat use. While most cases have been described from Europe and North America, chronic liver disease and cirrhosis of unknown cause are frequent in areas of the world where khat is commonly used.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Khat leaves have multiple components, some of which may be hepatotoxic. In animals, liver injury and fibrosis have been reproduced by chronic khat exposure. Interestingly, liver injury specifically related to khat has not been reported from areas of the world where it is commonly used, despite some studies specially focusing on the frequency of liver injury among chronic khat users. In these countries where Catha edulis is endemic and common, only freshly cut khat leaves are used and they are typically sold the day that they are harvested. Thus, the liver injury associated with khat use that has been reported from North America, Europe and Australia may be related to the storage and shipping of the leaves, either from a contaminant or a breakdown product during storage. There is a superficial resemblance of the liver injury from khat to that of amphetamines, particularly methylenedioxymethamphetamine (MDMA, ecstasy). Contamination with ecstasy might be done to enhance the euphoric effects of khat, especially in long stored leaves that typically have less cathinone due to its metabolism.

### Outcome and Management

The liver injury attributed to khat use can be severe and progressive, but resolution has been reported in patients who have stopped use of khat. Because khat use can result in psychological and physical dependence, stopping its regular use may be difficult. Corticosteroids are often used in patients who present with autoimmune features, but they appear to have little effect in khat related liver injury and should not be considered routine therapy. Liver transplantation has been successful in some patients, with end stage liver disease attributed to khat chewing.

Drug Class: Agents of Abuse; Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Recurrent acute hepatitis attributed to Khat.(1)

A 24 year old man presented with a one week history of jaundice and fatigue and was found to have abnormal liver tests. He was otherwise healthy, denied a history of alcohol or drug use, was taking no medications, and had no risk factors for viral hepatitis. Laboratory tests showed a total bilirubin of 11.2 mg/dL, ALT 2449 U/L, and AST 1388 U/L. Alkaline phosphatase levels were not provided. Importantly, the INR was elevated at 1.6 qualifying the case as being severe. Abdominal ultrasound was normal. A percutaneous liver biopsy showed a cholestatic hepatitis with eosinophils and plasma cells but little interface hepatitis. Tests for viral hepatitis, and other potential viral causes were negative. Over 8 days of hospitalization he improved clinically, and serum enzymes decreased (Table). After discharge he did not return for follow up but presented two months later with a similar acute history and similar laboratory abnormalities. At this point he admitted to use of khat. He was born in Somalia, lived for several years in India, and had immigrated to Canada three years previously. He admitted to chewing khat (a common practice among Somali immigrants) 4 or 5 times monthly in recent years in Canada. His prior use in Somalia was not provided. Again, his symptoms and laboratory abnormalities improved during an 8 day hospitalization but were still abnormal at discharge, the INR being 1.6. Note that the second episode was more severe, with an INR of 1.9 and a higher AST to ALT ratio. He was strongly advised to avoid further use of khat. He again did not return for follow up.

### Key Points

Medication: | Khat
Pattern: | Hepatocellullar (R=unable to calculate)
Severity: | 4+ (jaundice, hospitalization, INR prolonged)
Latency (https://www.ncbi.nlm.nih.gov/books/n/livertox/glossary/def-item/glossary.latency/): | Three years of weekly khat use
Recovery: | Uncertain in timing and degree
Other medications: | None

### Laboratory Values

Days After Stopping | ALT (https://www.ncbi.nlm.nih.gov/books/n/livertox/glossary/def-item/glossary.alanine-aminotransferase-alt-/) (U/L) | AST (U/L) | INR | Bilirubin (https://www.ncbi.nlm.nih.gov/books/n/livertox/glossary/def-item/glossary.bilirubin/) (mg/dL) | Other
1 | 2449 | 1388 | 1.6 | 11.1 | Admission
3 | 2284 | 1169 | 1.6 | 16.9 | Liver biopsy
8 | 1531 | 886 | 1.6 | 14.8 | Discharged
2 months | Did not return in follow up, and evidently returned to regular khat use
1 | 1827 | 1484 | 1.9 | 16.6 | Readmitted
3 | 1669 | 1373 | 1.6 | 12.8 | History of khat use obtained
8 | 914 | 646 | 1.6 | 6.4 | Discharged
Again, he did not return in follow up

### Comment

The history and presentation of this case were typical of khat hepatotoxicity as seen in Europe and North America. The onset can be sudden despite long term use and no previous symptoms or signs of liver injury. The liver biopsy showed acute hepatitis with scant fibrosis, but the injury was clearly severe and multiple such bouts would likely result in cirrhosis. The lack of mentioning khat use during the first admission and the lack of follow up are also typical of khat hepatotoxicity. It is illegal and addictive. The patient likely lacked medical insurance or resources to obtain regular medical care. The major psychotropic agent in khat is cathinone, an amphetamine-like central nervous system stimulant. Interestingly, the clinical presentation, course, and potential for causing cirrhosis with continued use resemble the liver injury from ecstasy (methylenedioxymethamphetamine: MDMA).

## PRODUCT INFORMATION

REPRESENTATIVE STREET NAMES

Khat – Abyssinian Tea, Chat, Gat, Kat, Miraa, Oat, Qat, Somali Tea

DRUG CLASS

Agents of Abuse; Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at Drug Enforcement Administration (https://www.dea.gov/factsheets/khat)

Information at Drug & Chemical Evaluation Section, Drug Enforcement Administration (https://www.deadiversion.usdoj.gov/drug_chem_info/khat.pdf)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cathinone | 5265-18-9 | C9-H11-N-O | SID: 135064802

## CITED REFERENCE

1 Waters M, Oxner A, Krajden S, Sultanian R. Acute liver injury associated with khat use in a 24-year-old male. Case Reports Hepatol. 2018;2018:2816907.30584482

## ANNOTATED BIBLIOGRAPHY

References updated: 29 January 2024

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; discussion of hepatotoxicity of herbal and dietary supplements does not include mention of khat).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements; does not mention or discuss khat).
Khat. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp 497-8. (Compilation of short monographs on herbal medications and dietary supplements including khat).
Khakoo SI, Coles CJ, Armstrong JS, Barry RE. Hepatotoxicity and accelerated fibrosis following 3,4-methylenedioxymetamphetamine ("ecstasy") usage. J Clin Gastroenterol 1995; 20: 244-7. (22 year old woman developed jaundice 3 months after starting weekly MDMA abuse [bilirubin 3.1 mg/dL, AST 2314 U/L, Alk P 145 U/L, protime 16.6 seconds] and, with continued intermittent ecstasy use and 6 months later, developed ascites and worsening jaundice [bilirubin 23.9 mg/dL, AST 2214 U/L, Alk P 253 U/L protime 24.1 seconds], biopsy showed fibrosis; partial response to prednisone). 7797836
Al-Motarreb A, Baker K, Broadley KJ. Khat: pharmacological and medical aspects and its social use in Yemen. Phytother Res 2002; 16: 403-13. (Review of the custom of khat use in Yemen and the Middle East, the chemical alkaloids present in khat leaves, the typical symptoms and side effects of its use, the adverse side effects, and social role of khat chewing in society, as well as its adverse effects on personal and family life). 12203257
Chaudier B, Oliver M, Coton T, Civatte M, Guisset M, Carré, Debonne JM, Delpy R. [Chronic hepatitis with an acute presentation due to Ecstasy]. Gastroenterol Clin Biol 2002; 26: 103-4. French. (18 year old female developed jaundice 3 weeks after taking 2 tablets of ecstasy [bilirubin 15.6 mg/dL, ALT 44 times ULN, GGT 1.4 times ULN, protime 96%], with subsequent worsening and liver biopsy showing chronic hepatitis with bridging fibrosis; 1 year later enzymes were normal, but liver biopsy showed chronic hepatitis with mild fibrosis). 11938056
Toennes SW, Harder S, Schramm M, Niess C, Kauert GF. Pharmacokinetics of cathinone, cathine and norephedrine after the chewing of khat leaves. Br J Clin Pharmacol 2003; 56: 125-30. (Formal pharmacokinetic study demonstrated effective extraction of cathinone and related alkaloids [>90%] from chewing khat leaves, probable oral absorption, high rapid peak levels and half life of 1.5 hours). 12848785
Carvalho F. The toxicological potential of khat. J Ethnopharmacol 2003; 87: 1-2. (Editorial on toxicological profile of khat, its common side effects being withdrawal symptoms, depression, irritability, anorexia, hyperthermia, and insomnia; long term use may be associated with hypertension, cardiovascular events and esophageal cancer). 12787946
D'Souza R, Sinnott P, Glynn MJ, Sabin CA, Foster GR. An unusual form of autoimmune hepatitis in young Somalian men. Liver Int 2005; 25: 325-30. (Comparison of clinical features of 6 Somalian men with suspected autoimmune hepatitis to 10 Caucasians with typical disease from the UK; the Somalis were more likely men [100% vs 30%], younger [mean age 37 vs 55 years], less likely to respond to corticosteroids [14% vs 80%], and less likely to have typical HLA alleles). 15780057
Al-Habori M. The potential adverse effects of habitual use of Catha edulis (khat). Expert Opin Drug Saf 2005; 4: 1145-54. (Review of adverse effects of chronic khat use; no discussion of hepatotoxicity). 16255671
Brostoff JM, Plymen C, Birns J. Khat--a novel cause of drug-induced hepatitis. Eur J Intern Med 2006; 17: 383. (35 year old East African man living in London developed jaundice and pruritus, having started using khat "recently" on a daily basis [bilirubin 10.6 mg/dL, ALT 2732 U/L, Alk P 231 U/L, ANA negative], ultimately resolving after stopping khat). 16864024
Graziani M, Milella MS, Nencini P. Khat chewing from the pharmacological point of view: an update. Subst Use Misuse 2008; 43: 762-83. (Review of the components, chemical structures, pharmacology, and actions of khat). 18473221
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% were attributed to herbal and dietary supplements, but none to khat). 18955056
Balint EE, Falkay G, Balint GA. Khat – a controversial plant. Wien Klin Wochenschr 2009; 121 (19-20): 604-14. (Thorough review of the history and current use of khat, its chemical constituents, pharmacology, biologic effects, and side effects; fibrosis and cirrhosis are listed as adverse effects, but not commented upon). 19921126
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 12 were attributed to herbal supplements, but none to khat). 20949552
Chapman MH, Kajihara M, Borges G, O'Beirne J, Patch D, Dhillon AP, Crozier A, et al. Severe, acute liver injury and khat leaves. N Engl J Med 2010; 362: 1642-4. (Brief description of 6 patients who were immigrants from Africa or the Arabian Peninsula living in the UK with severe liver disease attributed to chewing khat for 6-10 years, 5 requiring liver transplant, most with multiple episodes of acute liver injury [while in the UK], resulting in liver failure [bilirubin 9.6-23.3 mg/dL, ALT 244-2314 U/L, Alk P 193-258 U/L, INR 1.3-3.7]). 20427816
Peevers CG, Moorghen M, Collins PL, Gordon FH, McCune CA. Liver disease and cirrhosis because of Khat chewing in UK Somali men: a case series. Liver Int 2010; 30: 1242-3. (Brief description of 7 Somalian men seen over 10-year period in a UK referral center, ages 28-41 years, with acute or chronic severe hepatocellular injury, poorly responsive to corticosteroids [bilirubin 1.8-30.4 mg/dL, ALT 636-2140 U/L, ANA positive in one]). 20408953
Stuyt RJ, Willems SM, Wagtmans MJ, van Hoek B. Chewing khat and chronic liver disease. Liver Int 2011; 31: 434-6. (Report of 6 cases of khat associated liver disease from the Netherlands, all patients from East Africa, some presenting with jaundice and others with portal hypertension and advanced cirrhosis, ages 17-47 years, 6 men and 1 woman [bilirubin 1.2-35.5 mg/dL, ALT 18-1192 U/L, Alk P 42-235 U/L], 4 died). 21281438
Coton T, Simon F, Oliver M, Kraemer P. Hepatotoxicity of khat chewing. Liver Int 2011; 31: 434. (Letter in response to Peevers [2010] mentioning that they have never seen liver injury attributable to khat, despite a large population of khat users and analysis of 204 liver biopsies from heavy users in the Djibouti Republic in the Horn of Africa). 20825558
Douglas H, Boyle M, Lintzeris N. The health impacts of khat: a qualitative study among Somali-Australians. Med J Aust 2011; 195: 666-9. (Interviews with members of eastern African communities in Australia found that 55% reported khat use, but often did not reveal this to physicians and caregivers). 22171861
Roelandt P, George C, d'Heygere F, Aerts R, Monbaliu D, Laleman W, Cassiman D, et al. Acute liver failure secondary to khat (Catha edulis)-induced necrotic hepatitis requiring liver transplantation: case report. Transplant Proc 2011; 43: 3493-5. (26 year old Somalian man with progressive liver failure visiting Belgium from the UK who was a chronic khat user [bilirubin 2.0 rising to 34.1 mg/dL, ALT 372 U/L, Alk P 337 U/L], ultimately undergoing liver transplant). 22099826
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs, and supplements; does not mention khat or Catha edulis). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury discusses Chinese and Asian herbs, but does not mention khat or Catha edulis specifically). 23121117
Forbes MP, Raj AS, Martin J, Lampe G, Powell EE. Khat-associated hepatitis. Med J Aust 2013; 199: 498-9. (32 year old Somalian man developed jaundice and pruritus and gave a history of khat use for 7 years, recently having changed his supply [bilirubin 14.0 mg/dL, ALT 1880 U/L, Alk P 161 U/L, ANA 1:640], resolving slowly, but with 2 subsequent relapses despite denial of continued khat use). 24099213
Pateria P, de Boer B, MacQuillan G. Liver abnormalities in drug and substance abusers. Best Pract Res Clin Gastroenterol 2013; 27: 577-96. (Review of the frequency and causes of liver test abnormalities in substance abusers, mentions that khat use can cause severe acute and chronic liver injury). 24090944
Riyaz S, Imran M, Gleeson D, Karajeh MA. Khat (Catha Edulis) as a possible cause of autoimmune hepatitis. World J Hepatol 2014; 6: 150-4. (Among 6 long term users of khat who presented with acute hepatitis between 2005-2010 to a single UK referral center, all were male, ages 24 to 57 years, from Somalia or Yemen and had features of autoimmune hepatitis [5 with liver biopsy], and most responding at least partially to corticosteroid therapy). 24672645
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract; no cases were attributed to khat). 25043597
Pantano F, Tittarelli R, Mannocchi G, Zaami S, Ricci S, Giorgetti R, Terranova D, Busardò FP, Marinelli E. Hepatotoxicity Induced by "the 3Ks": Kava, Kratom and Khat. Int J Mol Sci 2016; 17: 580. (Review of the evidence for hepatotoxicity of kava, kratom and khat mentions the chronic liver injury that resembles an atypical autoimmune hepatitis). 27092496
Alhaddad OM, Elsabaawy MM, Rewisha EA, Salman TA, Kohla MA, Ehsan NA, Waked IA. Khat-induced liver injuries: A report of two cases. Arab J Gastroenterol 2016; 17: 45-8. (Two Yemeni men, 31 and 32 years old, with long term daily khat use presented with liver injury [bilirubin 5.4 and 6.1 mg/dL, ALT 400 and 275 U/L, Alk P 273 and 245 U/L, INR 1.1 and 1.4], biopsies showing interface hepatitis and fibrosis, and both improved spontaneously with stopping khat use). 27049456
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not include listing or discussion of khat). 27402097
Orlien SMS, Ismael NY, Ahmed TA, Berhe N, Lauritzen T, Roald B, Goldin RD, et al. Unexplained chronic liver disease in Ethiopia: a cross-sectional study. BMC Gastroenterol 2018; 18: 27. (Among 150 patients who presented with chronic liver disease and cirrhosis between 2015-2016 to two hospitals in Ethiopia, the cause was identified in only 67 [45%: HBV in 55, HCV in 2], and khat use was frequent both in the known and unknown etiology groups [84% vs 74%], while alcohol use was rare [9% vs 6%]). 29439653
Waters M, Oxner A, Krajden S, Sultanian R. Acute liver injury associated with khat use in a 24-year-old male. Case Reports Hepatol. 2018; 2018: 2816907. (24 year old Somalian male Canadian immigrant presented with acute hepatitis of unknown cause [bilirubin 11.1 mg/dL, ALT 2449 U/L, Alk P not given, INR 1.6], which improved during hospitalization without further follow up until 2 months later when he presented with similar injury at which point he was found to have been chewing khat weekly for the previous 3 years: Case 1). 30584482
Orlien SMS, Berhe NB, Morgan MY, Johannessen A. Khat-related liver disease in sub-Saharan Africa: neglected, yet important. Lancet Glob Health. 2019;7:e310. (Letter to the editor stressing the importance of khat as a cause of chronic liver disease in sub-Saharan Africa, particularly among men which is often not mentioned in review articles). 30784630
Vento S, Dzudzor B, Cainelli F, Tachi K. Khat-related liver disease in sub-Saharan Africa: neglected, yet important - Authors' reply. Lancet Glob Health. 2019;7:e311. (Reply to Orlien et al [2019] mentioning that khat use is highest in Yemen, Somalia, and Eastern Africa, but not particularly common in most Western sub-Saharan countries). 30784631
Alhaddad O, Elsabaawy M, Abdelsameea E, Abdallah A, Shabaan A, Ehsan N, Elrefaey A, et al. Presentations, causes and outcomes of drug-Induced liver injury in Egypt. Sci Rep. 2020;10(1):5124. (Among 75 cases of drug induced liver injury admitted to a tertiary hospital in Egypt over a one year period, the most common causes were diclofenac [41%], amoxicillin-clavulanate [19%], halothane [11%], ibuprofen (5%], and khat [4%: 3 cases, all hepatocellular and self-limited in course]). 32198411
Palacios Argueta P, Attar B, Sikavi C, Alagiozian-Angelova V, Mishra S. Drug-induced liver injury caused by "Khat," an herbal stimulant. ACG Case Rep J. 2020;7:e00480. (28 year old Yemeni male immigrant to the US developed jaundice having chewed khat recreationally for 3 years [bilirubin 6.1 mg/dL, ALT 2148 U/L, Alk P 184 U/L, ANA negative, IgG 1490], improving on stopping khat but lost to follow up before liver tests became normal). 33299901
Malasevskaia I, Al-Awadhi AA, Mohammed L. Tea in the morning and khat afternoon: health threats due to khat chewing. Cureus. 2020;12:e12363. (Review of the history of khat use, its geographic prevalence, and profound effects on both physical and mental health including acute and chronic liver disease and death from cirrhosis). 33527046
Patel H, Kumar K, Essrani RK, Niazi M, Makker J, Nayudu SK. Acute hepatitis in a Yemeni immigrant associated with khat: a "biological amphetamine" carried in cultures. Clin Pract. 2021;11:167-173. (32 year old Yemeni male who had immigrated to the US one year previously developed abdominal pain and abnormal liver tests [bilirubin 0.7/2.0 mg/dL, ALT 328 U/L, Alk P 78 U/L], admitting to khat use 5-6 times monthly but much less than previously in Yemen, with improvement after stopping and normal liver tests 3 weeks later). 33800126
Shaikhain G, Gaballah M, Alhazmi A, Khardali I, Hakami A, Oraiby M, Alharbi S, et al. Fatalities involving khat in Jazan, Saudi Arabia, 2018 to 2021. Toxics. 2023;11:506. (Among 651 fatalities undergoing forensic analysis in a Saudi Arabian region over a 4 year period, 30 [5%] had postmortem samples positive for khat, highest levels in urine, the most common causes of death being suicide, homicide, or accident; no mention of hepatic pathology or cirrhosis). 37368606

## OTHER REFERENCE LINKS

Recent References on Khat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Khat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Khat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Khat)